# Enzyme Elevations Without Jaundice

Description. The most commonly observed form of drug induced liver injury is appearance of serum aminotransferase or alkaline phosphatase elevations (or both) without jaundice and with minimal or no symptoms. This phenotype can be further characterized based upon the relative elevations of serum ALT and Alk P (R ratio of ALT to Alk P, both expressed in multiples of the upper limit of normal) into hepatocellular (R >5), mixed (R=2 to 5) or cholestatic (R <2).

Latency to Onset. The onset of serum enzyme elevations is usually 2 to 12 weeks after starting the medication, but may be as long as 48 weeks.

Symptoms. Symptoms rarely accompany transient serum enzyme elevations without jaundice that arise during therapy and, if present, are usually mild and nonspecific such as fatigue, nausea, anorexia or vague right upper quadrant discomfort.

Serum Enzyme Elevations. ALT or alkaline phosphatase (Alk P) levels rise above normal, but rarely above 20 times the upper limit of the normal range (ULN) for ALT or 5 times ULN for Alk P without the development of jaundice and symptoms. Asymptomatic enzyme elevations may be transient and detected only because of routine monitoring or may be found during evaluation of an unrelated problem. Serum enzymes improve rapidly (within 2 to 4 weeks) of stopping the medication, but also may improve spontaneously even with continuation of drug (which is sometimes referred to as "adaption"). The appearance of serum enzyme elevations during drug therapy often leads to the decision to decrease the dose or stop the medication, but the level or duration of elevations that calls for such a decision is often unclear. The occurrence of symptoms or jaundice should lead to prompt discontinuation. In addition, any elevation of ALT above 10 times the ULN and persistent elevations above 3 times the ULN are appropriate criteria to stop a medication, particularly if it has been implicated in causing severe drug induced liver injury or is a new medication with uncertain potential for hepatotoxicity.

Drugs. Almost all medications have been associated with a 1% to 5% rate of asymptomatic serum enzyme elevations during the first few months of therapy, but the pattern is most typical of isoniazid, the antiretroviral agents, methotrexate, tacrine, aspirin and acetaminophen. The rate of serum enzyme elevations is also dependent upon the criteria for "elevations" and the frequency of monitoring.

Criteria for Definition. Elements important in defining serum enzyme elevations without jaundice include:

1 Latency of 2 to 48 weeks
2 No or minimal and nonspecific symptoms
3 Serum ALT rising above normal but less than 20 times ULN, and/or
4 Alkaline phosphatase levels rising above normal but less than 5 times ULN
5 Bilirubin not rising to levels associated with jaundicel (total <2.5 mg/dL)
6 Spontaneous decrease into the normal range or improvement on stopping medication within 4 weeks.

Serum enzyme elevations accompanied by rises in serum bilirubin above normal, but not to a level that might be considered adequate for jaundice (total bilirubin between 1.2 and 2.5 mg/dL), might be better described as "anicteric hepatitis" (if the enzyme pattern is hepatocellular) or "anicteric cholestatic hepatitis" (if the enzyme pattern is cholestatic or mixed).

## Representative Cases

### Case 1 and 2. Transient and persistent hepatocellular pattern of serum enzyme elevations during isoniazid therapy.

[Modified from: Mitchell JR, Long MW, Thorgeirsson UP, Jollow DJ. Acetylation rates and monthly liver function tests during one year of isoniazid preventive therapy. Chest 1975; 68: 181-90. PubMed Citation]

Among 218 patients with latent tuberculosis (positive tuberculin skin test) treated with a one year course of isoniazid, 8 developed elevations in both AST and bilirubin, but none developed clinically apparent hepatitis. The course of AST and bilirubin elevations from two patients (table 4 from the publication: cases 1 and 2) are shown.

#### Key Points

Medication: | Isoniazid (300 mg daily for 52 weeks)
Pattern: | Hepatocellular (Alk P values not given)
Severity: | 2+ (jaundice, not hospitalization)
Latency: | 4 and 16 weeks to elevations in AST
Recovery: | 20 weeks despite continuation in one patient; persistent AST elevations in the second
Other medications: | None mentioned

#### Laboratory Values

Weeks After Starting | Case #1 | | Case #2 | | Other
Weeks After Starting | AST (U/L) | Bilirubin (mg/dL) | AST (U/L) | Bilirubin (mg/dL)
0 | 16 | 0.3 | 19 | 0.5 | Isoniazid started
4 | 135 | 0.9 | 35 | 0.4
8 | 663 | 5.2 | 37 | 0.4
12 | 412 | 3.6 | 49 | 0.4
16 | 78 | 1.2 | 92 | 0.4
20 | 37 | 1.4 | 181 | 0.6
24 | 29 | 1.1 | 342 | 0.6
28 | 22 | 1.2 | 920 | 4.9
32 | 22 | 1.3 | 201 | 1.8
40 | 20 | 0.6 | 77 | 0.6
48 | 18 | 0.9 | 124 | 0.7
52 | 15 | 0.8 | 138 | 0.6 | Isoniazid stopped
After | 17 | 1.3 | 62 | 0.6
Normal | <30 | <1.2 | <30 | <1.2

#### Comment

Despite developing evidence of liver injury with jaundice, these two patients continued therapy with isoniazid and recovered completely (#1) or partially (#2). Serum aminotransferase elevations occur in 10% to 20% of patients treated with isoniazid for 1 year, but levels are usually minimally elevated and transient and are uncommonly (~10%) associated with symptoms. The aminotransferase elevations generally arise within the first 12 weeks of therapy, but can appear as late as 48 weeks. In up to 5% of patients, aminotransferase levels rise to at least 3 times the upper limit of normal and a proportion of these patients develop jaundice. It is prudent to stop therapy for any elevation of ALT or AST above 5 fold the upper limit of normal or for sustained values above 3 times the upper limit of normal, and certainly for any symptoms or appearance of jaundice. However, as shown in these two cases, "adaptation" and spontaneous recovery can occur even with fairly high aminotransferase elevations. The difficulty is that isoniazid related hepatic injury can be sustained and severe and result in acute liver failure. Furthermore, there are no reliable predictive features for recovery versus progressive damage. In this study, the laboratory testing was done in retrospect and results were not available until the study was over. Because the patients did not have symptoms of liver injury, therapy was continued.

### Case 3. Mild anicteric hepatitis after telithromycin therapy.

(DILIN Case: 102-0030)

A 31 year old man was treated with two 5 day courses of telithromycin for sinusitis. Five days after finishing the second course, he developed fever and chills and was found to have abnormal liver tests. On hospital admission, his ALT was 589 U/L but bilirubin was normal (Table). He had no previous history of liver disease or jaundice and drank little alcohol. He took antihistamines and used a nasal spray for his sinusitis, but took no medications chronically and had no drug allergies. Tests for hepatitis A, B and C were negative. Tests for anti-smooth muscle and antinuclear antibodies were weakly positive (1:80). A computed tomography scan of the abdomen showed no evidence of gallstone disease or obstruction. His serum aminotransferases fluctuated and peaked at levels of 15 to 25 times the upper limit of the normal range, but then gradually declined. Six weeks after admission he was without symptoms and laboratory tests were completely normal.

#### Key Points

Medication: | Telithromycin (800 mg daily for 5 days)
Pattern: | Hepatocellular (R=43)
Severity: | 1+ (no jaundice)
Latency: | 2 weeks after starting second course
Recovery: | 2 months
Other medications: | Brompheniramine tannate, mometasone nasal spray, rarely acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Second 5 day course of telithromycin (800 mg daily) . 1 week after the first
10 days | 5 days | 589 | 43 | 0.7 | Admission
12 days | 7 days | 1091 | 35 | 1.2 | INR 1.5
2 weeks | 10 days | 553 | 35 | 0.8 | INR 1.3
| 2 weeks | 768 | 47 | 1.1
| 3 weeks | 359 | 59 | 1.1 | Discharge
1 month | 4 weeks | 151 | 65 | 0.4
2 months | 7 weeks | 36 | 40 | 0.7 | INR 1.0
Normal Values | | <42 | <110 | <1.2

#### Comment

While the clinical phenotype of injury was serum enzyme elevations without jaundice, the pattern might be better described as anicteric, acute hepatitis. This patient developed symptoms of liver disease with marked elevations in serum ALT levels (>20 times ULN) but without jaundice within 10 days of starting a second course of oral telithromycin. Worrisome was a slight increase in prothrombin time, but this reversed with time and after vitamin K injections. Serum aminotransferases remained elevated for several weeks, but ultimately recovery was complete. The first course of telithromycin may have sensitized this patient; a history of previous exposure to macrolide antibiotics is not uncommon in patients presenting with liver injury. This patient should be cautioned not to receive telithromycin again.

### Case 4. Transient serum aminotransferase elevations due to pharmacologic doses of acetaminophen.

[Modified from: Watkins PB, Kaplowitz N, Slattery JT, Colonese CR, Colucci SV, Stewart PW, Harris SC. Aminotransferase elevations in healthy adults receiving 4 grams of acetaminophen daily: a randomized controlled trial. JAMA 2006; 296: 87-93. PubMed Citation]

A healthy volunteer was started on acetaminophen in a dose of 4 grams daily as a part of a randomized controlled study of the pharmacokinetics and safety of acetaminophen combinations. After 4 days, serum ALT levels began to rise and acetaminophen was stopped on day 7 when ALT levels rose above 3 fold elevated (Table). ALT levels continued to rise peaking at a level of 575 U/L on day 11 and slowly decreased thereafter. The patient had no history of liver disease, tested negative for hepatitis virus markers and remained asymptomatic.

#### Key Points

Medication: | Acetaminophen (4 grams daily)
Pattern: | Hepatocellular (R=14) [alkaline phosphatase levels normal]
Severity: | Mild (ALT elevations without jaundice)
Latency: | 7 days
Recovery: | ~2 weeks
Other medications: | None

#### Laboratory Values

Days After Starting | Days After Stopping | ALT* (U/L) | Acetaminophen Levels* (mcg/dL) | Other
0 | | 35 | 0 | Acetaminophen first dose
1 | | 35 | 4.0
2 | | 35 | 4.5
3 | | 45 | 4.0 | Pharmacokinetic study
4 | | 70 | 3.5
5 | | 80
6 | 0 | 135 | 3.0 | Acetaminophen stopped
7 | 1 | 310
8 | 2 | 470 | 0
9 | 3 | 490
10 | 4 | 575 | 0
11 | 5 | 520
12 | 6 | 420 | 0
13 | 7 | 330
14 | 8 | 260
16 | 9 | 160
17 | 10 | 130
18 | 11 | 105
Normal Values | | <40 | 0

* Estimated from Figure 3.

#### Comment

Serum enzyme elevations without jaundice occurred in 81 of 106 patients (76%) receiving acetaminophen in doses of 4 grams daily by mouth during this experimental study, in which patients were monitored almost daily during therapy. In half of patients, ALT levels rose above 2 times ULN (>80 U/L), 39% above 3 times (>120 U/L), 25% above 5 times (>200 U/L), and 8% above 8 times (>320 U/L). The case shown above had one of the highest elevations observed in the study. Typically, ALT levels began to rise after 3 to 7 days and remained elevated for 1 to 11 days. No patient became jaundiced and there were no clear cut symptoms associated with the elevations. Patients with ALT levels rising above 3 times ULN had acetaminophen stopped, but levels continued to rise for a few days as in this patient, whose ALT level was 575 U/L 5 days after stopping the drug and at a point that acetaminophen levels were undetectable. In some individuals, serum ALT levels fell back into the normal range despite continuing acetaminophen, a phenomenon referred to as "adaption".

### Case 5. Acute self limited serum enzyme elevations during ketoconazole therapy.

[Modified from: Leal-Cerro A, GarcíLuna PP, Jiméz Mejí E, Astorga R. [Hepatotoxicity of ketoconazole in patients with adrenal pathology]. Med Clin (Barc) 1987; 88: 519. PubMed Citation]

A woman was started on ketoconazole as experimental therapy of Cushing's syndrome and had regular blood test monitoring for liver injury at weekly intervals (Table). Serum ALT levels became abnormal after 14 days and peaked at 21 days, with minimal increase in serum alkaline phosphatase and no increase in serum bilirubin or appearance of symptoms. ALT levels fell to normal by week 5 despite continuation of ketoconazole at the same dose.

#### Key Points

Medication: | Ketoconazole (daily)
Pattern: | Hepatocellular (R=7.0)
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 14 days
Recovery: | 2 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL)
0 | 37 | 26 | 145 | 0.2
1 week | 30 | 19 | 162 | 0.3
2 weeks | 353 | 166 | 260 | 0.3
3 weeks | 79 | 38 | 252 | 0.4
4 weeks | 34 | 33 | 212 | 0.3
5 weeks | 36 | 33 | 215 | 0.3
Normal Values | <50 | <50 | <279 | <1.2

#### Comment

A typical example of mild to moderate serum enzyme elevations during the first few weeks of ketaconazole therapy, with spontaneous resolution despite continuing therapy without dose modification.

### Case 6. Cholestatic pattern of serum enzyme elevations during erlotinib therapy.

[Modified from: Saif MW. Erlotinib-induced acute hepatitis in a patient with pancreatic cancer. Clin Adv Hematol Oncol 2008; 6: 191-9. PubMed Citation]

A 52 year old man with locally advanced pancreatic cancer developed rising serum enzyme elevations 7 weeks after starting erlotinib therapy. Several months earlier, he had presented with jaundice and was found to have a mass in the head of the pancreas that was shown to be adenocarcinoma by thin need aspiration. He was treated first with biliary stenting followed by gemcitabine, oxaliplatin and external beam radiation. Because of unresectability and oxaliplatin induced neuropathy, he was then treated with gemcitabine and erlotinib. His baseline liver tests were mildly abnormal and he was monitored carefully during erlotinib therapy. Seven weeks after stating erlotinib, serum ALT and alkaline phosphatase levels began to rise (Table). He was maintained on erlotinib and gemcitabine and monitored more carefully. Eleven weeks into treatment, however, serum enzymes had risen to more than 5 times the upper limit of the normal range. Tests for hepatitis A, B and C were negative and he was taking no other medications. Abdominal imaging showed no interval change in the pancreatic mass and no evidence of extrahepatic obstruction. Erlotinib was stopped and he was maintained on gemcitabine alone. Liver enzymes decreased to baseline values within the ensuing 8 weeks.

#### Key Points

Medication: | Erlotinib (100 mg daily)
Pattern: | Cholestatic (R=1.9)
Severity: | 1+ (serum enzyme elevations only)
Latency: | 7-13 weeks
Recovery: | 8 weeks
Other medications: | Gemcitabine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Total Bilirubin (mg/dL) | Other
6 months | | 39 | 85 | 0.5
0 | | 53 | 176 | 0.5 | Erlotinib started
4 weeks | | 41 | 144 | 0.3
6 weeks | | 76 | 145 | 0.5
9 weeks | | 70 | 162 | 0.4 | CT scan: no change
11 weeks | | 131 | 283 | 0.3
13 weeks | 0 | 193 | 376 | 0.7 | Erlotinib stopped
14 weeks | 1 weeks | 199 | 346 | 0.3
15 weeks | 2 weeks | 288 | 491 | 0.4
16 weeks | 3 weeks | 157 | 444 | 0.2
19 weeks | 6 weeks | 85 | 259 | 0.3
22 weeks | 9 weeks | 62 | 176 | 0.4
Normal Values | | <35 | <130 | <1.2

#### Comment

The patient developed gradual increases in serum aminotransferase and alkaline phosphatase levels while being treated with erlotinib, and therapy was discontinued when ALT levels reached 5 times the upper limit of the normal range (considered Grade 3 toxicity). The severity of the liver injury, however, should be considered mild, as there was no jaundice and apparently no symptoms of hepatic injury. Because the patient had pancreatic cancer, the abnormalities could have indicated progressive malignant disease, particularly because of the cholestatic pattern of the enzymes and their gradual rise. However, imaging showed no evidence of an increase in the size of the pancreatic mass or evidence of biliary obstruction, and the abnormalities resolved once erlotinib was stopped. Grade 3 elevations in serum ALT levels are reported to occur in 5% to 10% of patients treated with erlotinib and gemcitabine, and this rate is only slightly higher than occurs with gemcitabine alone.

## Hepatic Histology of Serum Enzyme Elevations without Jaundice

[Under Construction]